# Chamomile

## OVERVIEW

### Introduction

Chamomile is an aromatic oil extracted from the flowers or leaves of the daisy-like plants including German chamomile (Matricaria recutita) and Roman or English chamomile (Chamaemelum nobile). Extracts, oils and teas made from chamomile are used for its soothing qualities as a sedative, mild analgesic and sleep medication. Chamomile has not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Chamomile (kam' o myle) is the common name for several daisy-like plants, the flowering tops of which are used to make teas, liquid extracts, capsules or tablets. The chamomile most commonly used for its hypnotic and sedative effects is German chamomile (Matricaria recutita). Chamomile extracts contain volatile oils, flavonoids and hydroxycoumarins. The flavonoid apeginin has benzodiazepine-like activity and is believed to be the active component of the herbal. Chamomile has multiple biologic effects in vitro and in vivo, including antiinflammatory, antioxidant, analgesic and sedative effects. In humans, chamomile has been claimed to induce relaxation and sedation and has been used to treat nervousness and insomnia. It is also used for cough, bronchitis, fever, wounds, mouth ulcers, burns, circulatory disorders, dyspepsia, depression and hair loss. Chamomile oils are commonly used in aromatherapy and are found in many skin lotions, creams, soaps and cosmetics. Chamomile is most often used as an herbal tea, but can also be inhaled, applied topically, or taken orally as tablets or capsules usually in combination with other herbals such as passionflower, aloe or valerian or with mild analgesics or antihistamines. Chamomile has not been approved for use in any medical condition in the United States, but it is found in several hundred over-the-counter preparations. Side effects are uncommon may include nausea, dizziness and allergic reactions.

### Hepatotoxicity

Despite widescale use, chamomile has not been convincingly linked to instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: German Chamomile, Blue Chamomile, Wild Chamomile, True Chamomile, Manzanilla, Matricaire.

Drug Class: Herbal and Dietary Supplements

See also Drug Class: Sedatives and Hypnotics, Herbals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chamomile – Generic (OTC Products)

DRUG CLASS

Herbal and Dietary Supplements

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chamomile)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chamomile | 8002-66-2 | Unspecified | No Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 24 May 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, jin bu huan, germander, chaparral leaf, skullcap and valerian, but not chamomile).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; chamomile is not discussed).
German Chamomile. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc., 2007: pp. 357-62. (Compilation of short monographs on herbal medications and dietary supplements).
Gyllenhaal C, Merritt SL, Peterson SD, Block KI, Gochenour T. (2000). Efficacy and safety of herbal stimulants and sedatives in sleep disorders. Sleep Med Rev. (Review of herbals used for sleep disorders; mentions that the sedative effects of chamomile are mild, but that clinical studies are lacking and allergic reactions to it have been reported).
Wheatley D. (2005). Medicinal plants for insomnia: a review of their pharmacology, efficacy and tolerability. J Psychopharmacol. (Review of herbals used to treat insomnia; mentions that chamomile is widely regarded as a mild tranquillizer and sleep inducer; no mention of side effects).
Meolie AL, Rosen C, Kristo D, Kohrman M, Gooneratne N, Aguillard RN, Fayle R, et al., Clinical Practice Review Committee. (2005). American Academy of Sleep Medicine. Oral nonprescription treatment for insomnia: an evaluation of products with limited evidence. J Clin Sleep Med. (Systematic review of efficacy of nonprescription treatments for insomnia states that German chamomile is used for restlessness and insomnia, but clinical studies of its efficacy are lacking and its side effects may include vomiting, allergic reactions and drug-herb interactions).
Singh O, Khanam Z, Misra N, Srivastava MK. (2011). Chamomile (Matricaria chamomilla L.): An overview. Pharmacogn Rev. (Review of the history of use, growth and harvest, chemical constituents, and uses of chamomile in cosmetics, perfumes and as a therapeutic agent, having been used in traditional medicine for thousands of years, initially Egypt, Greece and Rome, usually for gastrointestinal complaints as an antispasmodic but also as an antiseptic and analgesic, and more recently for its anxiolytic and sedative properties).
Sarris J, Panossian A, Schweitzer I, Stough C, Scholey A. (2011). Herbal medicine for depression, anxiety and insomnia: a review of psychopharmacology and clinical evidence. Eur Neuropsychopharmacol. (Overview and summary of herbals used to treat anxiety, depression and insomnia; ranks chamomile as having evidence level "B" for efficacy in anxiety in humans).
(2012). Drugs for insomnia. Treat Guidel Med Lett. (Guidelines for therapy of insomnia; mentions herbal products that are claimed to have sleep inducing effects including valerian root, kava, chamomile tea, passionflower, hops, lemon balm, lavender and skull cap, but that there is no convincing evidence for their efficacy and that the purity of commercially available over-the-counter products is suspect).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to chamomile).
El Mihyaoui A, Esteves da Silva JCG, Charfi S, Candela Castillo ME, Lamarti A, Arnao MB. (2022). Chamomile (Matricaria chamomilla L.): A review of ethnomedicinal use, phytochemistry and pharmacological uses. Life (Basel). (Extensive review of the chemical properties and activities of chamomile in vitro and in vivo and the basis of claims that it has anti-spasmodic, anti-bacterial, anti-viral, anti-fungal, anti-inflammatory, anti-neoplastic, immunomodulatory and anxiolytic activity; no discussion of its toxicity).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not mention chamomile).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not mention chamomile).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to chamomile).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to chamomile).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava [62 and greater celandine [48]; mentions that there is one case report of sinusoidal obstruction syndrome attributed to chamomile).

## OTHER REFERENCE LINKS

1 Recent References on Chamomile: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Chamomile/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Chamomile: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chamomile)